# Necitumumab

## OVERVIEW

### Introduction

Necitumumab is a human monoclonal antibody to the epidermal growth factor (EGF) receptor and is an anti-angiogenesis agent used in the therapy of advanced non-small cell lung cancer. Necitumumab has not been linked to serum enzyme elevations during therapy or to idiosyncratic acute liver injury.

### Background

Necitumumab (ne" si toom' ue mab) is a recombinant human monoclonal IgG1 antibody to the epidermal growth factor (EGF) receptor. The engagement of EGF with its receptors results in activation of cellular pathways that promote cell growth and angiogenesis. EGF receptors are often overexpressed in cancer cells, particularly squamous non-small cell lung cancer. Inhibition of EGF receptor signaling decreases cell growth and proliferation and decreases formation of new blood vessels, which plays an important role in growth and spread of cancer cells. When used in combination with other antineoplastic agents, necitumumab was shown to extend recurrence-free survival in several forms of advanced cancer. Necitumumab was approved in the United States in 2015 for use in metastatic squamous, non-small cell lung cancer as a part of combination therapy with gemcitabine and cisplatin. Necitumumab is available in solution in single use vials of 800 mg in 50 mL (16 mg/mL) under the brand name Portrazza. The typical dose is 800 mg given intravenously over at least 60 minutes on days 1 and 8 of each 3-week cycle. It is typically given in combination with other antineoplastic agents, most commonly with gemcitabine and cisplatin. Common adverse events include rash and hypomagnesemia, but when combined with other agents, diarrhea, fatigue, anorexia, epistasis, neutropenia, and stomatitis are frequent. Uncommon, but potentially severe adverse events include arterial and venous thromboembolic events, cardiopulmonary arrest, marked hypomagnesemia, severe infusion reactions and embryofetal toxicity.

### Hepatotoxicity

In large clinical trials, serum aminotransferase elevations were no more frequent in patients receiving necitumumab than placebo in combination with gemcitabine and cisplatin (35% vs 31%) and were rarely above 5 times the upper limit of normal (0.6% vs 1%). In these studies, there were no liver related serious adverse events or drug discontinuations for serum enzyme elevations. Subsequent to its approval and more general use, necitumumab has not been implicated in published cases of clinically apparent liver injury. Necitumumab is generally given with other potent antineoplastic agents and it is often difficult to attribute serum enzyme elevations or more clinically significant liver injury to one specific agent being used. Nevertheless, significant liver injury from necitumumab is probably uncommon.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which necitumumab might cause liver injury is unknown. Necitumumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity. Inhibition of EGF signaling does not seem to materially affect liver function.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Necitumumab – Portrazza®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Necitumumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Necitumumab | 906805-06-9 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 29 May 2017

Abbreviations used: NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; no specific discussion of necitumumab).
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Thatcher N, Hirsch FR, Luft AV, Szczesna A, Ciuleanu TE, Dediu M, Ramlau R, et al.; SQUIRE Investigators. Necitumumab plus gemcitabine and cisplatin versus gemcitabine and cisplatin alone as first-line therapy in patients with stage IV squamous non-small-cell lung cancer (SQUIRE): an open-label, randomised, controlled phase 3 trial. Lancet Oncol 2015; 16: 763-74. (Among 1093 patients with advanced squamous NSCLC treated with gemcitabine and cisplatin, overall survival was improved by addition of necitumumab [median 11.5 vs 9.9 months] as were serious adverse events [48% vs 38%], common side effects attributable to necitumumab being rash and hypomagnesemia; ALT and AST elevations occurred with equal frequency [35% vs 31% and 29% vs 25%] and were rarely above 5 times ULN [≤1%]). 26045340
Paz-Ares L, Mezger J, Ciuleanu TE, Fischer JR, von Pawel J, Provencio M, Kazarnowicz A, et al.; INSPIRE investigators. Necitumumab plus pemetrexed and cisplatin as first-line therapy in patients with stage IV non-squamous non-small-cell lung cancer (INSPIRE): an open-label, randomised, controlled phase 3 study. Lancet Oncol 2015; 16: 328-37. (Among 633 patients with non-squamous NSCLC treated with pemetrexed and cisplatin with or without necitumumab, there were no differences in overall survival rates [median 11.3 vs 11.5 months], but severe adverse events were more frequent with necitumumab [51% vs 41%] including higher rates of severe rash [18% vs <1%], hypomagnesemia [8% vs 2%] and venous thromboembolic events [8% vs 4%]; no mention of ALT elevations or hepatotoxicity). 25701171
Garnock-Jones KP. Necitumumab: First global approval. Drugs 2016; 76: 283-9. (Review of the development, pharmacology, mechanism of action, clinical efficacy and safety of necitumumab; does not mention ALT elevations or hepatotoxicity). 26729188
Elez E, Hendlisz A, Delaunoit T, Sastre J, Cervantes A, Varea R, Chao G, et al. Phase II study of necitumumab plus modified FOLFOX6 as first-line treatment in patients with locally advanced or metastatic colorectal cancer. Br J Cancer 2016; 114: 372-80. (Among 44 patients with advanced colorectal cancer treated with necitumumab, oxaliplatin, folinic acid and fluorouracil, objective responses occurred in 64% and adverse events included rash in 90% and neutropenia in 82%; no mention of ALT elevations or hepatotoxicity). 26766738
Paz-Ares L, Socinski MA, Shahidi J, Hozak RR, Soldatenkova V, Kurek R, Varella-Garcia M, et al. Correlation of EGFR-expression with safety and efficacy outcomes in SQUIRE: a randomized, multicenter, open-label, phase III study of gemcitabine-cisplatin plus necitumumab versus gemcitabine-cisplatin alone in the first-line treatment of patients with stage IV squamous non-small-cell lung cancer. Ann Oncol 2016; 27: 1573-9. (Among 982 patients with advanced squamous NSCLC enrolled in a controlled trial of necitumumab [Thatcher 2015] whose tumor could be evaluated, EGF protein expression was associated with a survival benefit with necitumumab; no mention of ALT elevations or hepatotoxicity). 27207107

## OTHER REFERENCE LINKS

1. Recent References on Necitumumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Necitumumab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Necitumumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Necitumumab)